# Umbralisib

## OVERVIEW

### Introduction

Umbralisib is an oral kinase inhibitor that is was given accelerated approved for use in adults with relapsed or refractory marginal zone and follicular lymphoma in 2021, but the approval was withdrawn a year later because of data from a trial showing excess mortality with its use. Umbralisib was associated with a modest rate of serum enzyme elevations during therapy but was not reported to cause clinically apparent acute liver with symptoms or jaundice.

### Background

Umbralisib (um" bra lis' ib) is an orally available, small molecule inhibitor of multiple kinases that play a role in B cell malignant cellular pathways and that was used in the therapy of refractory cases of marginal zone and follicular lymphoma. The kinases inhibited by umbralisib include phosphatidylinositol 3-kinase delta (PI3Kδ), which is an essential component in the B cell signaling pathways that drive migration of B cells to lymph nodes and bone marrow. This pathway is upregulated in many B cell malignancies and has been shown to be critical for proliferation and survival of leukemia and lymphomatous malignant B lymphocytes. Inhibition of this pathway inhibits B cell chemotaxis and adherence and reduces cell viability. Umbralisib also has activity against casein kinase epsilon which plays a role in protein synthesis and RNA translation and is altered in some malignancies. Other activities of umbralisib include inhibition of cell adhesion molecules and other kinases including BCR-ABL1. Studies in animal models and in early phase clinical trials showed that umbralisib had activity against several hematologic malignancies. Umbralisib was given tentative approval for use in the United States as therapy for refractory or relapsed marginal zone and follicular lymphoma after failure of one or more systemic therapies in February 2021. A little over a year later, FDA approval was withdrawn because of concerns about excess mortality in patients receiving Umbralisib in follow up clinical trials. The deaths on treatment were not liver related but the nature and relatedness of the mortality to umbralisib therapy was not well defined. Umbralisib was previously available in tablets of 200 mg under the brand name Ukoniq. The recommended dose was 800 mg once daily until disease progression or unacceptable toxicity. Side effects of umbralisib were common but usually mild-to-moderate in severity, and included fatigue, nausea, diarrhea, headache, musculoskeletal pain, stomatitis, fever, pain, rash, and infections. Common laboratory abnormalities included cytopenias, liver enzyme elevations, hyper- or hypo-glycemia, and hyponatremia. Severe potential adverse events included neutropenia, severe infections, severe diarrhea, allergic and hypersensitivity reactions, and embryo-fetal toxicity. Because of excess mortality among umbralisib- in comparison to placebo-treated patients, FDA approval was withdrawn in June 2022 and the product was withdrawn by the sponsor.

### Hepatotoxicity

In clinical trials of umbralisib in adults with lymphoma, the rates of serum enzyme elevations during therapy ranged from 15% to 35% and were above 5 times the ULN in 5% to 8% and occasionally above 20 times ULN (<1%). The aminotransferase elevations arose within 4 to 12 weeks of starting therapy in most instances and usually resolved without dose modification or temporary discontinuation. Nevertheless, there were no instances of serum enzyme elevations accompanied by jaundice and no liver related deaths.

Because umbralisib affects B cell function, it may also be capable of inducing reactivation of hepatitis B, although in published trials of the agent, instances of HBV reactivation were not reported.

Likelihood score: E* (unproven, but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why umbralisib causes serum enzyme elevations is not known, but may be a direct toxicity to hepatocytes caused by inhibition of PI3K activity or the result of change in B cell activity and caused by induction of autoimmunity. Umbralisib is metabolized primarily by aldehyde oxidase which is present in many tissues, but highest concentrations are in the liver. The cytochrome P450 system plays a minor role in the metabolism (CYP 3A4) of umbralisib, but concentrations may be affected by drugs that induce or inhibit CYP 3A activity.

### Outcome and Management

Serum enzyme elevations were not uncommon during chemotherapy with umbralisib and were often dose limiting. The product label recommended that umbralisib not be used with other agents with hepatotoxic potential. Furthermore, regular monitoring of liver tests every 2 to 4 weeks was recommended during the first six months of umbralisib therapy and every 1 to 3 months thereafter, with more frequent monitoring if serum aminotransferase values rise. It was recommended that umbralisib be held if ALT or AST values rise above 5 times ULN, and treatment resumed only if and when values fall into the normal range and then with a reduced dose and careful monitoring. Elevations of aminotransferase values of more than 20 times the ULN, or appearance of jaundice or symptoms of liver injury were considered to require permanent discontinuation. There was no known cross sensitivity to hepatic injury between umbralisib and other protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other PI3 Kinase Inhibitor Drugs: Alpelisib, Copanlisib, Duvelisib, Idelalisib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Umbralisib – Ukoniq® [On June 1, 2022, FDA approval was withdrawn due to safety concerns.]

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING [No Longer Available]

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Umbralisib | 1532533-67-7 | C31-H24-F3-N5-O

## ANNOTATED BIBLIOGRAPHY

References updated: 10 October 2023

Abbreviations: CLL, chronic lymphocytic leukemia; PI3K, phosphatidylinositol 3-kinase.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of small molecular weight kinase inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss umbralisib or other PI3K inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/213176Orig1Orig2s000TOC.cfm (FDA website with initial multidiscipline clinical review of the safety and efficacy of umbralisib; states that the overall objective response rate was 49% in adults with refractory marginal zone lymphoma [n=69] and the serious adverse event rate [n=371 in a pooled safety cohort] was 26% resulting in discontinuation in 15%, while ALT elevations arose in 15-17%, which were above 5 times ULN in 7-8% and led to discontinuation in 3%, but there were instances of liver injury with jaundice or deaths from liver failure).
Furman RR, Sharman JP, Coutre SE, Cheson BD, Pagel JM, Hillmen P, Barrientos JC, et al. Idelalisib and rituximab in relapsed chronic lymphocytic leukemia. N Engl J Med 2014; 370: 997-1007. (Among 220 patients with relapsed CLL treated in a placebo controlled trial, progression free survival improved with idelalisib and rituximab compared to rituximab alone, but side effects were more common with the combination including ALT or AST elevations [35% vs 19%], which were above 5 times ULN in 5% vs 1% and led to drug discontinuations in some patients, but there were no clinically apparent cases of liver injury). 24450857
Curigliano G, Shah RR. Safety and Tolerability of phosphatidylinositol-3-kinase (PI3K) inhibitors in oncology. Drug Saf. 2019;42:247-262. (Review of the safety of PI3K inhibitors which are associated with serious adverse events in up to 60% of patients, more commonly when given in combination with other antineoplastic agents, with both infectious and immune related events which can be severe and involve skin [Stevens Johnson syndrome], lung [pneumonitis], colon [colitis], and liver [usually aminotransferase elevations]). 30649751
Burris HA 3rd, Flinn IW, Patel MR, Fenske TS, Deng C, Brander DM, Gutierrez M, et al. Umbralisib, a novel PI3Kδ and casein kinase-1ε inhibitor, in relapsed or refractory chronic lymphocytic leukaemia and lymphoma: an open-label, phase 1, dose-escalation, first-in-human study. Lancet Oncol. 2018;19:486-496. (Among 90 patients with various forms of refractory or relapsed lymphoma or leukemia enrolled in a phase 1 dose escalating study of umbralisib [50 to 1800 mg daily] in 28 day cycles, the optimal dose identified was 800 mg daily and common adverse events included diarrhea, nausea, fatigue, myelosuppression and infections; 7 patients developed liver enzyme elevations which were above 5 times the ULN in 3 and led to drug discontinuation in 2 patients). 29475723
Davids MS, Kim HT, Nicotra A, Savell A, Francoeur K, Hellman JM, Bazemore J, et al.; Blood Cancer Research Partnership of the Leukemia and Lymphoma Society. Umbralisib in combination with ibrutinib in patients with relapsed or refractory chronic lymphocytic leukaemia or mantle cell lymphoma: a multicentre phase 1-1b study. Lancet Haematol. 2019;6:e38-e47. (Among 42 patients with refractory or relapsed chronic lymphocytic leukemia [CLL] or mantle cell lymphoma treated with umbralisib [400, 600 or 800 mg daily] and ibrutinib [420 or 560 mg daily] for a median of 22 months, the overall response rate was 90% for CLL and 67% for mantle cell lymphoma, while adverse events were common and included ALT or AST elevations in 24% which were above 5 times the ULN in only 1 patient [2% ]). 30558987
Mato AR, Ghosh N, Schuster SJ, Lamanna N, Pagel JM, Flinn IW, Barrientos JC, et al. Phase 2 study of the safety and efficacy of umbralisib in patients with CLL who are intolerant to BTK or PI3Kδ inhibitor therapy. Blood. 2021;137:2817-2826. (Among 51 adults with refractory chronic lymphocytic leukemia [CLL] who were switched to umbralisib, progression free survival was 24 months and adverse events included pneumonia, neutropenia, rash, and diarrhea, while ALT or AST elevations occurred in 14% which were above 5 times ULN in 6% and led to dose interruptions but no discontinuations, and no patient developed clinically apparent liver injury). 33259589
Fowler NH, Samaniego F, Jurczak W, Ghosh N, Derenzini E, Reeves JA, Knopińska-Posłuszny W, et al. Umbralisib, a dual PI3Kδ/CK1ε Inhibitor in patients with relapsed or refractory indolent lymphoma. J Clin Oncol. 2021;39:1609-1618. (Among 208 adults with refractory lymphomas treated with umbralisib [800 mg daily] for a median of 28 months, the overall response rate was 86%, while 99% had at least one adverse event, most commonly diarrhea [59%], nausea [39%], fatigue [31%], cough {20%], but also rash [2%] and ALT elevations [20%], which were above 5 times ULN in 7% and led to early discontinuation in 2.4%, but there were no liver enzyme elevations accompanied by jaundice or liver related deaths). 33683917
Smith SD, Gopal AK. Umbralisib: walking the tightrope of PI3K inhibition in indolent NHL. J Clin Oncol. 2021;39:1671-1673. (Editorial in response to Fowler et al [2021] mentions that umbralisib has specificity for the delta [δ} isoform of PI3K kinase which is found in hematopoietic cells and plays a critical role in B cell development and function, suggesting that umbralisib may have higher potency and fewer adverse effects that more non-specific anti-PI3K inhibitors). 33861621
Roskoski R Jr. Properties of FDA-approved small molecule phosphatidylinositol 3-kinase inhibitors prescribed for the treatment of malignancies. Pharmacol Res. 2021;168:105579. (Comprehensive review of the structure, function, clinical efficacy, indications, and status of the PI3K inhibitors currently approved and in use in the US, including idelalisib [2014], copanlisib [2017], duvelisib [2018], alpelisib [2019] and umbralisib [2021, withdrawn 2022]). 33774181
Davids MS, O'Connor OA, Jurczak W, Samaniego F, Fenske TS, Zinzani PL, Patel MR, et al. Integrated safety analysis of umbralisib, a dual PI3Kδ/CK1ε inhibitor, in relapsed/refractory lymphoid malignancies. Blood Adv. 2021;5:5332-5343. (Analysis of pooled results from 4 open label trials of umbralisib in 371 adults with various forms of refractory or relapsed non-Hodgkin’s lymphoma found adverse event rate of 99% overall with the most common being diarrhea [52%], nausea [42%], and fatigue [32%] and any ALT or AST elevation in 63 patients [17%] which were above 5 times ULN in 7%, but there were no treatment related deaths and no instances of clinically apparent liver injury with jaundice). 34547767
Dhillon S, Keam SJ. Umbralisib: first approval. Drugs. 2021;81:857-866. (Summary of the mechanism of action, history of development, pharmacodynamics, clinical efficacy and safety of umbralisib shortly after its approval for use in the US, mentions that ALT elevations arise in up to 33% of patients and are above 5 times ULN in 8% leading to early discontinuation in 5%). 33797740
FDA. https://www.fda.gov/drugs/drug-safety-and-availability/fda-approval-lymphoma-medicine-ukoniq-umbralisib-withdrawn-due-safety-concerns (FDA letter announcing the withdrawal of approval of umbralisib due to the finding of excess mortality in a controlled trial of the combination of umbralisib with ublituximab [U2] compared to standard therapy for lymphoma; the sponsor also announced the voluntary withdrawal of umbralisib).

## OTHER REFERENCE LINKS

Recent References on Umbralisib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Umbralisib/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

Trials on Umbralisib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Umbralisib)